# Loratadine

## OVERVIEW

### Introduction

Loratadine and its metabolic derivative desloratadine are second generation antihistamines that are used for the treatment of allergic rhinitis, angioedema and chronic urticaria. Loratadine and desloratadine have been linked to rare, isolated instances of clinically apparent acute liver injury.

### Background

Loratadine (lor at' a deen) and desloratadine (des" lor at' a deen) are second generation antihistamines (H1 receptor blockers) that are used widely to treat allergic symptoms associated with hay fever, seasonal allergies, urticaria, angioedema and atopic dermatitis. Like other second generation antihistamines, loratadine and desloratadine are considered to be nonsedating, and prospective studies have shown that sedation is less common with them than first generation antihistamines such as diphenhydramine. Loratadine and desloratadine belong to the piperidine class of antihistamines (similar to fexofenadine). The two agents appear to have a similar spectrum of activity and side effects, although some patients are found to prefer one over the other. Loratadine was approved for use by prescription in the United States in 1993 and as an over-the-counter medication in 2002. It is available in 5 and 10 mg tablets and capsules generically and under the trade name Claritin. The typical dose is 10 mg once daily and it is often given chronically, at least during allergic season. Desloratadine, which is the major metabolite of loratadine, was approved for use in the United States in 2001 and is currently available by prescription only in tablets of 2.5 or 5 mg in multiple generic forms and under the trade name Clarinex. Common side effects of second generation antihistamines include blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Although considered to be nonsedating antihistamines, loratadine and desloratadine can cause mild drowsiness particularly at higher doses. Antihistamines can worsen urinary retention and glaucoma.

### Hepatotoxicity

Loratadine and desloratadine use are associated with a low rate of liver enzyme elevations which are usually asymptomatic, mild and self-limited even without modification of the dose. In addition, rare instances of clinically apparent liver injury attributed to loratadine and desloratadine use have been reported as isolated case reports. The time to onset of liver injury varied but was typically within 2 to 4 weeks of starting the medication. Most cases were associated with a hepatocellular pattern of enzyme elevations resembling acute viral hepatitis. Immunoallergic and autoimmune features were not described and most cases were self-limited in course. However, at least one fatal instance of acute hepatitis attributed to loratadine has been reported. In none of the cases, was there a clear link to loratadine and all had other possible or probable non-drug causes. Thus, loratadine and desloratadine have been convincingly implicated in cases of clinically apparent liver injury in the literature and the association is suspect only.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of acute liver injury from loratadine and desloratadine is not known. Loratadine is extensively metabolized by the liver, largely via the cytochrome P450 system (CYP 3A4 and 2D6).

### Outcome and Management

The mild and asymptomatic elevations in serum aminotransferase that have been observed during loratadine and desloratadine therapy are usually transient and may resolve even without dose modification. Clinically apparent liver injury due to these second generation antihistamines, however, generally calls for prompt withdrawal of the agent. Severe injury is uncommon and most cases resolve promptly upon withdrawal. Cases of chronic hepatitis or vanishing bile duct syndrome due to loratadine and desloratadine have not been described. There is no information about cross reactivity among the various antihistamines after clinically apparent hepatotoxicity, but switching to another agent with a different structure and belonging to a separate class is probably safe.

References on the safety and potential hepatotoxicity of antihistamines are given together after the Overview section on Antihistamines.

Drug Class: Antihistamines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Loratadine/Desloratadine – Generic, Claritin®/Generic, Clarinex®

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Loratadine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Loratadine | 79794-75-5 | C22-H23-Cl-N2-O2 | Loratadine Chemical Structure
Desloratadine | 100643-71-8 | C19-H19-Cl-N2 | Desloratadine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Loratadine and Desloratadine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Loratadine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Loratadine and Desloratadine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Loratadine)